# Betrixaban

## OVERVIEW

### Introduction

Betrixaban is an oral anticoagulant and direct inhibitor of factor Xa which is used to decrease the risk of deep vein thrombosis and pulmonary embolus in patients hospitalized with an acute medical condition who are at high risk for venous thromboses. Betrixaban has been linked to a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury.

### Background

Betrixaban (be trix' a ban) is an orally available, small molecule direct inhibitor of coagulation factor Xa (-xaban), the rate controlling last step in the generation of thrombin, the final intermediate in blood coagulation. Inhibiting thrombin prevents the conversion of fibrinogen to fibrin and subsequent cross linking of fibrin monomers, platelet activation and amplification of coagulation. Clinical trials have shown that anticoagulation with betrixaban can decrease the risk of deep vein thrombosis and pulmonary embolism in patients undergoing hospitalized with an acute medical illness that places them at high risk for thromboembolism. Betrixaban was approved for use in the United States in 2017 for prophylaxis of thromboembolism in patients hospitalized for an acute medical illness who are at moderate or high risk for thromboembolism. Betrixaban is available in 40 and 80 mg capsules under the commercial name Bevyxxa. The recommended dose is an initial single dose of 160 mg on day 1 followed by 80 mg once daily for 35 to 42 days. Lower doses are recommended for patients with renal dysfunction or on inhibitors of P-glycoprotein. Unlike warfarin, betrixaban does not require monitoring of bleeding time or INR. Side effects are not common, but can include bleeding, headache, dizziness, fatigue, gastrointestinal upset, nausea, arthralgias and rash. Uncommon, but potentially severe adverse events include severe bleeding episodes, epidural or spinal hematomas, and hypersensitivity reactions.

### Hepatotoxicity

In registration studies, serum aminotransferase elevations of greater than 3 times the upper limit of normal (ULN) occurred in 1% to 2% of betrixaban-treated patients and in a similar proportion of control subjects treated with enoxaparin. Similarly, aminotransferase levels rose to above 5 times ULN in 0.6% of betrixaban and 0.4% of enoxaparin treated control subjects. Aminotransferase elevations with jaundice arose in <0.2% of patients in both groups and all cases appeared to be due to heart disease and congestive liver injury and unrelated to the anticoagulants used. Since approval and more widespread clinical use, there have been no reports of clinically apparent liver injury due to betrixaban. On the other hand, other direct factor Xa inhibitors, such as apixaban and rivaroxaban, have been linked to rare instances of idiosyncratic liver injury, generally arising within days or a few weeks of starting and presenting with a mild-to-moderate hepatocellular injury without prominent immunoallergic and autoimmune features. This syndrome has not been reported with betrixaban, but it has had limited clinical use.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of the mild serum aminotransferase elevations during betrixaban therapy are unknown. Betrixaban has minimal hepatic metabolism and has no drug-drug interactions with substrates or modulators the cytochrome P450 system. Betrixaban is, however, a substrate of P-glycoprotein, potent inhibitors of which (such as amiodarone, azithromycin, clarithromycin, verapamil, ketoconazole) can cause elevated levels of betrixaban, increasing the risk of bleeding.

### Outcome and Management

Betrixaban has been associated with mild, asymptomatic and self-limited elevations in serum aminotransferases but not with hepatitis with jaundice. There have been no reports of fulminant hepatic failure attributed to betrixaban or cases of chronic hepatitis or vanishing bile duct syndrome. In some instances, patients with acute liver injury due to one direct factor Xa inhibitor (rivaroxaban) have tolerated another (apixaban) without recurrence of liver abnormalities.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants, Factor Xa Antagonists: Apixaban, Edoxaban, Fondaparinux, Rivaroxaban

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Betrixaban – Generic, Bevyxxa®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Betrixaban)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Betrixaban | 330942-05-7 | C23-H22-Cl-N5-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 16 February 2023

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-42. (Textbook of hepatotoxicity published in 1999 well before the availability of betrixaban and the direct Factor Xa inhibitors).
De Marzio DH, Navarro VJ. Antiplatelet agents. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 527-8. (Review of hepatotoxicity of cardiovascular drugs does not discuss the anticoagulants).
Hogg K, Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 585-604. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that rates of serum aminotransferase elevations during betrixaban therapy were similar to rates in patients treated with comparator anticoagulants [1.7% vs 1.5%] and the rare instances of clinically apparent liver injury with jaundice were all attributable to other causes such as heart failure and bacterial sepsis).
Turpie AG, Bauer KA, Davidson BL, Fisher WD, Gent M, Huo MH, Sinha U, et al., EXPERT Study Group. (2009). A randomized evaluation of betrixaban, an oral factor Xa inhibitor, for prevention of thromboembolic events after total knee replacement (EXPERT). Thromb Haemost. (Among 215 patients undergoing knee replacement surgery treated with betrixaban [15 or 40 mg twice daily] or enoxaparin [30 mg sc every 12 hours] for 10-14 days, venous thromboembolism was more frequent with betrixaban [15% and 20%] than enoxaparin [10%]; no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to anticoagulants).
Caldeira D, Barra M, Santos AT, de Abreu D, Pinto FJ, Ferreira JJ, Costa J. (2014). Risk of drug-induced liver injury with the new oral anticoagulants: systematic review and meta-analysis. Heart. (Systematic review of 29 controlled trials of oral anticoagulants in 152,116 patients focusing on risk of drug induced liver injury [including 7 trials with 22,992 patients on apixaban] found no increase in rate of serum ALT or AST elevations above 3 times ULN [1.0% vs 1.2%], or combined enzyme and bilirubin elevations above 2 times ULN [both 0.2%] with apixaban therapy compared to control patients on standard therapy).
Liakoni E, Rätz Bravo AE, Krähenbühl S. (2015). Hepatotoxicity of new oral anticoagulants (NOACs). Drug Saf. (Systematic review of evidence of hepatotoxicity of new oral anticoagulants including rivaroxaban, apixaban, edoxaban and dabigatran found 22 cases of liver injury due to rivaroxaban, 2 dabigatran, 2 apixaban, but none to edoxaban).
Anastasia EJ, Rosenstein RS, Bergsman JA, Parra D. (2015). Use of apixaban after development of suspected rivaroxaban-induced hepatic steatosis; a case report. Blood Coagul Fibrinolysis. (67 year old man developed ALT elevations 6 months after starting rivaroxaban [peak ALT 391 U/L, Alk P 120 U/L, bilirubin 1.3 mg/dL], which fell into the normal range within 2 months of switching to apixaban; ultrasound suggested fatty liver which also resolved with stopping).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two cases were attributed to anticoagulants(prasugrel and dalteparin), but none to direct factor Xa antagonists).
Cohen AT, Harrington RA, Goldhaber SZ, Hull RD, Wiens BL, Gold A, Hernandez AF, Gibson CM. (2016). APEX Investigators. Extended thromboprophylaxis with betrixaban in acutely ill medical patients. N Engl J Med. (Among 7513 patients hospitalized with acute medical illness and at risk of venous thromboembolism treated with betrixaban [80 mg daily for 35-42 days] or enoxaparin [40 mg sc once daily for 10-14 days], evidence of venous thromboembolism was found in 69% on betrixaban and 8.5% on enoxaparin; no mention of ALT elevations or hepatotoxicity).
Garland SG, DeRemer CE, Smith SM, Gums JG. (2018). Betrixaban: a new oral factor Xa inhibitor for extended venous thromboembolism prophylaxis in high-risk hospitalized patients. Ann Pharmacother. (Review of the pharmacology, clinical efficacy and safety of betrixaban; no mention of ALT elevations or hepatoxicity).
(2018). Comparison table: some oral anticoagulants for VTE. Med Lett Drugs Ther. (Table of oral anticoagulants used for VTE compares, indications, doses, adverse events and special issues; mentions adverse events of aminotransferase elevations for apixaban, edoxaban, rivaroxaban but not betrixaban or dabagatran).
(2018). Betrixaban (Bevyxxa) for VTE prophylaxis in acute medical illness. Med Lett Drugs Ther. (Concise review of the currently approved drugs for prevention of venous thromboembolism and the clinical efficacy, safety and costs of betrixaban; no mention of ALT elevations or hepatotoxicity).
(2018). Drugs for treatment and prevention of venous thromboembolism. Med Lett Drugs Ther. (Concise review of drugs approved for venous thromboembolism; mentions that betrixaban is approved for prophylaxis only and not treatment; no mention of hepatic side effects).
Björnsson HK, Gudmundsson DO, Björnsson ES. (2020). Liver injury caused by oral anticoagulants: A population-based retrospective cohort study. Liver Int. (Search of Icelandic National Prescription Databases and Health Records identified 3 cases of clinically apparent, acute liver injury in 3 of 3446 [0.1%] patients taking rivaroxaban, but in none of 9101 taking warfarin, 1903 apixaban, 1335 dabigatran or 34 taking edoxaban; betrixaban was not mentioned).
Yang X, Li N, Guo T, Guan X, Tan J, Gao X, Wu Y, Jia L, et al. (2020). Comparison of the effects of low-molecular-weight heparin and fondaparinux on liver function in patients with pulmonary embolism. J Clin Pharmacol. (Among 463 adults with pulmonary embolus treated with low molecular weight heparins or with fondaparinux, 79 [17%] developed evidence of liver injury that was generally mild and less than 3 times ULN in 98%, including 15% of 377 on edoxaban, 32% of 59 on nadroparin, and 7.4% of 27 on fondaparinux; no mention of betrixaban).
Zhao J, Blais JE, Chui CSL, Suh IH, Chen EYH, Seto WK, Mok MT, et al. (2020). Association between nonvitamin K antagonist oral anticoagulants or warfarin and liver injury: a cohort study. Am J Gastroenterol. (Among 13,698 patients with atrial fibrillation started on anticoagulant therapy and followed in the Hong Kong Clinical Database and Reporting system between 2010 and 2016, 513 [2.8%] developed evidence of liver injury and propensity matching indicated that liver injury was less frequent [2.1% vs 3.4%], although more severe with oral anticoagulants than with warfarin).
Maura G, Bardou M, Billionnet C, Weill A, Drouin J, Neumann A. (2020). Oral anticoagulants and risk of acute liver injury in patients with nonvalvular atrial fibrillation: a propensity-weighted nationwide cohort study. Sci Rep. (Among 434,015 patients with atrial fibrillation started on anticoagulant therapy and followed in the French National Healthcare Database, 218 [0.6%] were subsequently hospitalized for acute liver injury, the rates being similar for those on dabigatran [26 of 51,737 patients], apixaban [29 of 62,503 patients] and rivaroxaban [46 of 99,408 patients]; no mention of betrixaban).
Zhou J, Leung KSK, Kong D, Lee S, Liu T, Wai AKC, Chang C, et al. (2021). Low rates of liver injury in edoxaban users: Evidence from a territory-wide observational cohort study. Clin Cardiol. (Among 1213 patients with atrial fibrillation started on edoxaban between 2016 and 2020 and followed in the Hong Kong Clinical Database and Reporting System, 19 [1.5%] developed evidence of liver injury, a rate below that previously reported for warfarin [3.7%], apixaban [2.5%], and rivaroxaban [2.1%]).
Ma J, Chalasani NP, Schwantes-An L, Björnsson ES. (2023). Review article: the safety of anticoagulants and antiplatelet agents in patients with cirrhosis. Aliment Pharmacol Ther. (Review of the safety of anticoagulant use in patients with cirrhosis mentions that drug induced liver injury is uncommon in patients with preexisting cirrhosis, at least in those with compensated [Child’s Class A] or mildly compensated [Child’s Class B] cirrhosis).

## OTHER REFERENCE LINKS

1 Recent References on Betrixaban: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Betrixaban/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Betrixaban: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Betrixaban)